# Orforglipron

## OVERVIEW

### Introduction

Orforglipron is an orally available, glucagon-like peptide-1 (GLP-1) receptor agonist that is approved as a weight loss agent. Rates of serum aminotransferase elevations during orforglipron therapy are no higher than with placebo and it has not been linked to instances of clinically apparent liver injury with symptoms or jaundice.

### Background

Orforglipron (or” for glip’ ron) is an orally available, glucagon-like peptide-1 (GLP-1) receptor agonist that is used as a weight loss agent in patients who are obese or are overweight and have at least one weight-related comorbid condition. Orforglipron is a small molecule that binds to the GLP-1 receptor in the brain that regulates appetite and satiety. Engagement of the GLP-1 receptor results in a decrease in hunger and food intake leading to loss of excessive weight. Activation of GLP-1 receptors in the gastrointestinal tract and pancreas result in a decrease in gastric emptying, an increase in glucose-dependent insulin secretion, and suppression of glucagon secretion, all of which may add to the decrease in food intake. In clinical trials in adult humans, a 72-week course of orforglipron in the currently recommended dose given once daily resulted in loss of 11% of baseline body weight compared to 2% with placebo. Orforglipron was approved in the United States in 2026 to reduce excess body weight and maintain weight reduction long term. Unlike previously approved GLP-1 agonists, orforglipron is not a polypeptide analogue of GLP-1 but is a small molecule that mimics the binding qualities of GLP-1 to its receptor and can be taken by mouth. Orforglipron is available in tablets of 0.8, 2.5, 9.0, 14.5, and 17.2 mg under the brand name Foundayo. The recommended starting dose is 0.8 mg daily which should be gradually increased to 2.5, 9.0, 14.5 and 17.2 mg in 30-day intervals based upon efficacy and tolerance. The maximum dose is 17.2 mg. Common side effects include nausea, vomiting, bloating, and dyspepsia which may be dose limiting but usually decrease with time. Other mild adverse events may include constipation, diarrhea, abdominal pain, gastrointestinal reflux, eructation, fatigue, headaches, and hair loss. Rare but potentially severe adverse events include acute pancreatitis, acute gallbladder disease, severe gastrointestinal reactions, acute kidney injury (due to volume depletion), hypoglycemia (in patients on other antidiabetic medications), diabetic retinopathy complications, pulmonary aspiration during anesthesia, and hypersensitivity reactions.

### Hepatotoxicity

In pre-registration, controlled trials in more than 3,000 adults treated with orforglipron, mild serum ALT and AST elevations above normal were common with orforglipron therapy, but overall rates were similar to those in the placebo group (39% vs 41%). A small proportion of patients (0.9%) treated with orforglipron developed de novo elevations of ALT above 5 times the upper limit of normal (ULN), but again, a similar rate occurred with placebo therapy (0.9%), and on careful analysis, the abnormalities could be attributed to underlying or concurrent diseases (e.g., cholecystitis, viral hepatitis). Importantly, mean levels of ALT and AST fell during orforglipron but not placebo treatment, probably reflecting the effect of weight loss on underlying nonalcoholic fatty liver disease which is common in patients with overweight or obesity. No recipient developed liver injury with symptoms or jaundice that could not be explained by another condition.

Special attention was paid to the possibility of liver injury in studies of orforglipron because several other small molecule GLP-1 agonists had to be abandoned during early clinical development because of hepatotoxicity. Orforglipron has a chemical structure that is different from the previously abandoned agents, which may explain a lower risk of hepatotoxicity. Since its approval there have been no published cases of liver injury attributed to orforglipron, but clinical experience with the drug has been limited. Thus, orforglipron appears to have a safe liver profile, but because of the relatively limited experience with its use, the likelihood score should be considered preliminary.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which orforglipron might cause liver injury is not known. It is a complex molecule containing a pyrimidine core along with indazole and difluoro moieties. It is metabolized in the liver primarily by the microsomal enzyme, CYP 3A4. Liver injury might arise due to a toxic or immunogenic metabolite of orforglipron. It is susceptible to drug-drug interactions with strong inducers and inhibitors of the CYP 3A4. Also, because it alters gastric emptying, orforglipron may affect absorption of other medications.

### Outcome and Management

Orforglipron has not been linked to serious serum aminotransferase elevations during therapy nor to instances of clinically apparent liver injury. It is given long term and its potential for long-term adverse events remains unknown.

Drug Class: Weight Loss Agents

Other Drugs in the Subclass: Semaglutide, Liraglutide, Tirzepatide

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Orforglipron – Foundayo®

DRUG CLASS

Weight Loss Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=orforglipron)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Orforglipron | 2212020-52-3 | C48-H48-F2-N10-O5

## ANNOTATED BIBLIOGRAPHY

References updated: 01 June 2026

Abbreviations used: ULN, upper limit of normal; GLP-1, glucagon-like peptide-1.

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Expert review of hepatotoxicity published in 1999, before the availability of orforglipron).
Powers AC, D'Alessio D. Endocrine pancreas and pharmacotherapy of diabetes mellitus and hypoglycemia. In, Brunton LL, Hilal-Dandan R, Knollmann BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 863-86. (Textbook of pharmacology and therapeutics; discusses glucagon-like peptide-1 [GLP-1] and the incretin pathway and the agents that act on this pathway). (Drugs@FDA: FDA-Approved Drugs) https://www.accessdata.fda.gov/scripts/cder/daf/ (FDA website with product label and FDA integrated review of efficacy and safety of orforglipron, based upon data submitted by the sponsor in support of its approval as therapy for weight loss, mentions that in the large pre-registration randomized controlled trial in more than 3000 overweight or obese adults, ALT elevations above the ULN arose in 39% of orforglipron treated vs 41% of placebo treated subjects but were usually mild, and were above 3 times ULN in 2.5% vs 2.3% and above 5 times ULN in 0.9% vs 0.9% and the few patients with concurred ALT and bilirubin elevations had alternative causes [gallstone disease and hepatitis A]).
Kawai T, Sun B, Yoshino H, Feng D, Suzuki Y, Fukazawa M, Nagao S, et al. Structural basis for GLP-1 receptor activation by LY3502970, an orally active nonpeptide agonist. Proc Natl Acad Sci U S A. 2020;117:29959-29967. (Description of the development of orforglipron [LY3502970] based upon rational design of a candidate, small molecule GLP-1 receptor agonist that has different binding characteristics but similar intracellular signaling effects as native GLP-1). 33177239
Wharton S, Blevins T, Connery L, Rosenstock J, Raha S, Liu R, Ma X, et al.; GZGI Investigators. Daily oral GLP-1 receptor agonist orforglipron for adults with obesity. N Engl J Med. 2023;389:877-888. (Among 272 non-diabetic adults with obesity or overweight treated with 1 of 4 doses of orforglipron or placebo for 26 weeks, there was a dose-related 9% to 13% body weight loss of orforglipron vs 2% on placebo while adverse events arose in 86% to 90% vs 76% and were mostly mild-to-moderate gastrointestinal complaints, while serious adverse events were rare and there was no mention of ALT elevations or hepatotoxicity.). 37351564
Sloop KW, Cox AL, Wainscott DB, White A, Droz BA, Stutsman C, Showalter AD, et al. The pharmacological basis for nonpeptide agonism of the GLP-1 receptor by orforglipron. Sci Transl Med. 2024;16:eadp5765. (In rat and mouse models, orforglipron was found to have low receptor occupancy in comparison to peptide GLP-1 receptor agonists but had full pharmacological activity in enhancing glucose stimulated insulin secretion by the pancreas and activation of anorexigenic pathways in the central nervous system). 39693407
Rosenstock J, Hsia S, Nevarez Ruiz L, Eyde S, Cox D, Wu WS, Liu R, Li J, Fernández Landó L, Denning M, Ludwig L, Chen Y; ACHIEVE-1 Trial Investigators. Orforglipron, an oral small-molecule glp-1 receptor agonist, in early type 2 diabetes. N Engl J Med. 2025;393:1065-1076. (Among 559 adults with type 2 diabetes treated with 3, 12 or 36 mg of orforglipron or placebo daily for 40 weeks, there was a dose-related decline in glycated hemoglobin (HbA1c) levels [-1.24 to -1.48 vs -0.4] and weight loss, while adverse events were largely mild-to-moderate gastrointestinal complaints with rare severe adverse events [2 episodes of cholelithiasis, no pancreatitis] and mean ALT and AST levels decreased with treatment). 40544435
Wharton S, Aronne LJ, Stefanski A, Alfaris NF, Ciudin A, Yokote K, Halpern B, et al.; ATTAIN-1 Trial Investigators. Orforglipron, an oral small-molecule glp-1 receptor agonist for obesity treatment. N Engl J Med. 2025;393:1796-1806. (Among 3127 adults with obesity or overweight treated with orforglipron [6, 12, or 24 mg] vs placebo once daily for 72 weeks, mean body weight change was -7.5% to -11.2% vs -2.1% while adverse events arose in 83% to 87% vs 81% and were mostly mild-to-moderate gastrointestinal complaints, serious adverse events occurred in 3.8-5.5% vs 4.9% [including pancreatitis in 5 treated patients], and ALT elevations above 5 times ULN arose in 0.8% to 1.3% vs 0.9%, and all ALT elevations with jaundice had alternative causes [cholelithiasis and hepatitis A]). 40960239
Rosenstock J, Yabe D, Cox D, Li J, Denning M, Wu WS, Liu R, Zhao Y; ACHIEVE-3 Investigators. Efficacy and safety of once-daily oral orforglipron compared with oral semaglutide in adults with type 2 diabetes (ACHIEVE-3): a multinational, multicentre, non-inferiority, open-label, randomised, phase 3 trial. Lancet. 2026;407(10534):1147-1160. (Among 1698 adults with poorly controlled type 2 diabetes treated with orforglipron [12 or 36 mg] or semaglutide [7 or 14 mg] orally once daily for 52 weeks, changes in HbA1c levels were -1.71% and -1.91% vs -1.23% and -1.47%] while gastrointestinal adverse events leading to discontinuations were 9% and 10% vs 4% and 5%, serious adverse events 5% and 9% vs 4% and 6%, and ALT elevations above 3 times ULN 1.4% and 1.1% vs 3.5 and 1.9%; there were no hepatic serious adverse events). 41765029
Aronne LJ, Horn DB, le Roux CW, Chao AM, Ho W, Halpern B, Griffin R, et al. Orforglipron for maintenance of body weight reduction: the double-blind, randomized phase 3b ATTAIN-MAINTAIN trial. Nat Med. 2026 May 13. Epub ahead of print. (Among 205 patients treated with tirzepatide and 171 with semaglutide switched to orforglipron [up to 36 mg daily] or placebo for 52 weeks, maintenance of weight loss was greater with orforglipron and adverse event rates were similar in both groups in both cohorts, ALT elevations above 5 times ULN arose in only 1 patient in each group combining both cohorts). 42120723
Orforglipron (Foundayo) - a second oral GLP-1 receptor agonist for weight loss. Med Lett Drugs Ther. 2026;68(1755):81-83. PMID: (Concise review of the mechanism of action, clinical efficacy, safety, and costs of orforglipron shortly after its approval in the United States as a weight loss agent; mentions that adverse effects can include gastrointestinal intolerance, acute pancreatitis, acute gallbladder disease, acute renal failure, and diabetic retinopathy complications, but does not mention ALT elevations or hepatotoxicity). 42139026
Horn DB, Ryan DH, Kis SG, Alves B, Mu Y, Kim SG, Aberle J, et al.; ATTAIN-2 Trial Investigators. Orforglipron, an oral small-molecule GLP-1 receptor agonist, for the treatment of obesity in people with type 2 diabetes (ATTAIN-2): a phase 3, double-blind, randomised, multicentre, placebo-controlled trial. Lancet. 2026;406(10522):2927-2944. (Among 1613 patients with type 2 diabetes treated with orforglipron [6, 12, or 36 mg] or placebo once daily for 72 weeks, mean weight loss was -5.1% to -9.6% vs -2.5% and discontinuations for adverse events 6.1% to 9.9% vs 4.1%, no mention of ALT elevations or hepatotoxicity). 41275875

## OTHER REFERENCE LINKS

1. Recent References on Orforglipron: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Orforglipron%20+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Orforglipron: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Orforglipron)